# Oxybate

## OVERVIEW

### Introduction

Oxybate is a small, neuroactive molecule (gamma-hydroxybutyrate) that is used to treat catalepsy and daytime sleepiness in patients with narcolepsy. Oxybate has been reported to cause serum enzyme elevations during therapy, but has not been implicated in instances of clinically apparent acute liver injury.

### Background

Oxybate (ox' i bate) is a simple amino acid-like molecule (sodium 4-hydroxybutyrate) that has mild neuroactivity which acts to induce normal sleep patterns. Its mechanism of action is unclear, but it is a derivative of gamma-aminobutyric acid (GABA) and appears to be an agonist at the GABA-B receptor. In prospective, randomized controlled trials, oxybate was effective in alleviating symptoms of daytime sleepiness and decreasing episodes of cataplexy in patients with narcolepsy. Oxybate was approved for use in the United States in 2002 as therapy for cataplexy in patients with narcolepsy. These indications were broadened in 2005 to include improvement in the quality of nighttime sleep and decrease in daytime sleepiness in patients with narcolepsy. Although evaluated and reported to be partially beneficial in other conditions (fibromyalgia, chronic fatigue, alcohol abstinence), oxybate is not approved for these indications. In addition, oxybate is a Schedule III agent, indicating that it has a mild-to-moderate potential for abuse and dependence. For these reasons, the availability of oxybate is restricted, and it can only be prescribed as a part of a risk evaluation and mitigation strategy (REMS) program. Oxybate sodium is available as an oral solution in 180 mL bottles of 500 mg/mL under the brand name Xyrem. In addition, a low-sodium formulation has been developed consisting of calcium, magnesium, potassium and sodium salts of oxybate and is available in a similar oral solution of 500 mg/mL under the brand name Xywav. The recommended starting dose of both formulations of oxybate is 4.5 g at nighttime, which can be increased or decreased at two week intervals in increments of 1.5 g, not to exceed 9 g daily. Common side effects include nausea, dizziness, headaches, mental confusion, paresthesia and enuresis (bed wetting). Uncommon, but potentially severe adverse reactions (usually associated with excessive doses) include hallucinations, mental confusion, abnormal thinking, disturbed sleep and depression. Instances of abuse and dependence as well as withdrawal symptoms have been described, but are rare. Hydroxybutyrate has been used as a “date rape” drug and it has been implicated in rare instances of acute psychosis, traffic accidents and suicidal overdose.

### Hepatotoxicity

In preregistration clinical trials, serum enzyme elevations were reported in small numbers of treated patients, but no instance of clinically apparent liver injury was reported. Since the approval and more widespread use of oxybate, there have been no published cases of liver injury due to oxybate, and in postmarketing overviews of adverse events hepatotoxicity was not listed. Thus, despite use in high doses (3 to 9 g daily), acute liver injury from oxybate must be very rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which oxybate might cause liver injury is not known. Hydroxybutyrate is an endogenous derivative of GABA and thus is unlikely to be inherently hepatotoxic or immunogenic.

Drug Class: CNS Stimulants, Narcolepsy Agents

Other Drugs in the Subclass, Narcolepsy Agents: Amphetamines, Armodafinil, Dextroamphetamine, Modafinil, Methylphenidate, Pitolisant, Solriamfetol

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sodium Oxybate – Xyrem®

DRUG CLASS

Narcolepsy Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Oxybate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sodium Oxybate | 502-85-2 | C4-H7-Na-O3
Sodium gamma-Aminobutyrate | 6610-05-5 | C4-H9-N-O2.Na

## ANNOTATED BIBLIOGRAPHY

References updated: 18 August 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999, before the availability of oxybate).
Westfall TC, Macarthur H, Westfall DP. Narcolepsy and sleep/wake imbalance. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 207. (Textbook of pharmacology and therapeutics).
(1991). Gamma hydroxy butyrate poisoning. Med Lett Drugs Ther. (Hydroxybutyrate is promoted and sold in health food stores illegally for sleep and weight control and for its euphoric effects and has been linked to cases of abrupt unconsciousness, coma, respiratory depression, seizures, and abnormal behavior).
(2002). A randomized, double blind, placebo-controlled multicenter trial comparing the effects of three doses of orally administered sodium oxybate with placebo for the treatment of narcolepsy. Sleep. (Among 136 patients with narcolepsy and episodes of cataplexy who were treated with oxybate [3, 6 or 9 g daily] or placebo, the highest dose of oxybate was associated with decrease in episodes of cataplexy and decrease in daytime sleepiness, and adverse events included nausea, diarrhea, dizziness and enuresis but there was “no measurable effect on…hepatic or renal function”).
(2002). Gamma hydroxybutyrate (Xyrem) for narcolepsy. Med Lett Drugs Ther. (Concise review of the mechanism of action, pharmacology, efficacy, adverse effects, and costs of gamma hydroxybutyrate [oxybate] shortly after its approval as therapy for narcolepsy in the US; mentions its neuropsychiatric side effects, but not ALT elevations or hepatotoxicity).
Scharf MB, Baumann M, Berkowitz DV. (2003). The effects of sodium oxybate on clinical symptoms and sleep patterns in patients with fibromyalgia. J Rheumatol. (Among 24 women with fibromyalgia treated with oxybate or placebo for 1 month in a crossover trial, pain and fatigue were improved in 29-33% of oxybate- vs only 6-10% of placebo-recipients and side effects included gastrointestinal upset, anxiety, headache and paresthesias; there were no serious adverse events and no mention of ALT elevations or hepatotoxicity).
U.S. Xyrem Multicenter Study Group. (2003). A 12-month, open-label, multicenter extension trial of orally administered sodium oxybate for the treatment of narcolepsy. Sleep. (Among 118 patients with narcolepsy who had participated in a placebo controlled trial [U.S. Xyrem, 2002] who were treated with open label oxybate [3-9 g nightly] for 12 months, episodes of cataplexy decreased and daytime sleepiness decreased and “adverse events were generally mild” while “only a mild increase in SGPT was determined to be possibly related to the study medication” and no patient discontinued therapy for this reason).
U.S. Xyrem Multicenter Study Group. (2004). Sodium oxybate demonstrates long-term efficacy for the treatment of cataplexy in patients with narcolepsy. Sleep Med. (Among 55 patients with narcolepsy treated with oxybate for 7-44 months who were then randomized to continue or stop oxybate for 2 weeks, the frequency of cataleptic episodes increased with stopping [median increase 21 vs 0]).
Xyrem International Study Group. (2005). A double-blind, placebo-controlled study demonstrates sodium oxybate is effective for the treatment of excessive daytime sleepiness in narcolepsy. J Clin Sleep Med. (Among 228 patients with narcolepsy and cataplexy treated with oxybate [4.5, 6 or 9 g nightly] or placebo for 8 weeks, those on the two highest doses had improvement in wakefulness; side effects included nausea, dizziness, enuresis, disorientation, dyspnea, snoring and muscle pains; 1 patient developed elevated levels of ALT and AST that gradually resolved after stopping).
(2006). A new indication for gamma hydroxybutyrate (Xyrem) in narcolepsy. Med Lett Drugs Ther. (Concise review of narcolepsy and the mechanism of action, clinical efficacy, and adverse effects of oxybate, shortly after the broadening of its indications to include excessive daytime sleepiness in patients with narcolepsy; no mention of serum enzyme elevations or hepatotoxicity).
Wang YG, Swick TJ, Carter LP, Thorpy MJ, Benowitz NL. (2009). Safety overview of postmarketing and clinical experience of sodium oxybate (Xyrem): abuse, misuse, dependence, and diversion. J Clin Sleep Med. (Analysis of the postmarketing adverse event surveillance, including 928 reports from an estimated 26,000 patients taking oxybate over a 6 year period mentions rare instances of abuse [n=10], dependence [4], withdrawal symptoms [8], overdose [8], sexual assault [2], traffic accidents [3] and one death thought to be related; no mention of liver related effects among the 20 most common adverse events).
Russell IJ, Perkins AT, Michalek JE, Oxybate SXB-26 Fibromyalgia Syndrome Study Group. (2009). Sodium oxybate relieves pain and improves function in fibromyalgia syndrome: a randomized, double-blind, placebo-controlled, multicenter clinical trial. Arthritis Rheum. (Among 188 patients with fibromyalgia treated with oxybate [4.5 or 6 g nightly] or placebo for 8 weeks, oxybate was associated with improvements in pain scores and side effects included nausea, dizziness, paresthesia, headache and enuresis, but “there were no clinically important changes in…laboratory measures”).
Spaeth M, Alegre C, Perrot S, Wang Y, Guinta DR, Alvarez-Horine S, Russell I, Sodium Oxybate Fibromyalgia Study Group. (2013). Long-term tolerability and maintenance of therapeutic response to sodium oxybate in an open-label extension study in patients with fibromyalgia. Arthritis Res Ther. (Among 560 women with fibromyalgia who had participated in short controlled trials of oxybate and were then offered open label extended therapy [4.5-9 g nightly], symptom improvement was maintained and side effects were similar to those in short term studies; there were no liver related serious adverse events and no mention of ALT elevations).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to oxybate or other therapies for narcolepsy or excessive sleepiness).
Mamelak M, Swick T, Emsellem H, Montplaisir J, Lai C, Black J. (2015). A 12-week open-label, multicenter study evaluating the safety and patient-reported efficacy of sodium oxybate in patients with narcolepsy and cataplexy. Sleep Med. (Among 202 patients with narcolepsy with cataplexy treated with open label, titrated doses of oxybate [3-9 g nightly] for 12 weeks, 90% were considered to have had a clinical response and side effects included nausea [10%], headache [7%], dizziness [5%] and enuresis [2%], while “overall changes in laboratory tests were minimal”).
Drakatos P, Lykouras D, D'Ancona G, Higgins S, Gildeh N, Macavei R, Rosenzweig I, et al. (2017). Safety and efficacy of long-term use of sodium oxybate for narcolepsy with cataplexy in routine clinical practice. Sleep Med. (Among 90 patients with narcolepsy started on oxybate at a single medical center between 2009 and 2015 [3116 patient-months of exposure], sleepiness scores and cataplexy events improved in doses of 4.5-9 g nightly, but 27% of patients stopped therapy because of side effects [mostly nausea, mood swings and enuresis]; in long list of side effects there was no mention of ALT elevations or hepatotoxicity).
Plazzi G, Ruoff C, Lecendreux M, Dauvilliers Y, Rosen CL, Black J, Parvataneni R, et al. (2018). Treatment of paediatric narcolepsy with sodium oxybate: a double-blind, placebo-controlled, randomised-withdrawal multicentre study and open-label investigation. Lancet Child Adolesc Health. (Among 63 children [ages 7 to 16 years] with narcolepsy treated with oxybate or placebo, daytime sleepiness scores and cataplexy events decreased with oxybate therapy, while adverse events included enuresis [21%], nausea [22%], vomiting [21%], headache [18%], weight loss [15%], and dizziness [5%] while “no notable findings of clinical relevance were observed in clinical laboratory values”).
Mayer G, Plazzi G, Iranzo Á, Ortega-Albás J, Quinnell T, Pesch H, Serralheiro P, et al. (2018). Long-term compliance, safety, and tolerability of sodium oxybate treatment in patients with narcolepsy type 1: a postauthorization, noninterventional surveillance study. Sleep. (Among 640 adults with narcolepsy started on oxybate in 41 medical centers in Europe between 2006 and 2016, side effects were reported in 67% and led to discontinuation in 9%, usually for nausea, depression or dizziness; no liver related serious adverse events or discontinuations and no mention of ALT elevations or hepatotoxicity).
Addolorato G, Lesch OM, Maremmani I, Walter H, Nava F, Raffaillac Q, Caputo F. (2020). Post-marketing and clinical safety experience with sodium oxybate for the treatment of alcohol withdrawal syndrome and maintenance of abstinence in alcohol-dependent subjects. Expert Opin Drug Saf. (Systematic review of safety of oxybate therapy for alcohol withdrawal syndrome identified 3 controlled trials [520 patients], 43 pilot studies [2547 patients] and a pharmacovigilance safety information database [299,013 patients], reported most common adverse events to be dizziness [11%], headache [4%], fatigue 3.5%], and nausea [8%] with serious adverse events of depression, suicidal ideation, overdose, and epilepsy; no mention of ALT elevations or hepatotoxicity).
Husain AM, Bujanover S, Ryan R, Scheckner B, Black J, Profant J. (2020). Incidence and duration of common, early-onset adverse events occurring during 2 randomized, placebo-controlled, phase 3 studies of sodium oxybate in participants with narcolepsy. J Clin Sleep Med. (Post-hoc analysis of two placebo controlled trials of oxybate in adults with narcolepsy found that side effects were greatest at week one [dizziness, headache and nausea] and decreased thereafter; no mention of ALT elevations or hepatotoxicity).
Thorpy MJ. (2020). Recently approved and upcoming treatments for narcolepsy. CNS Drugs. (Review of the mechanism of action, pharmacology, drug-drug interactions, clinical efficacy and safety of newly approved medications for narcolepsy including pitolisant and solriamfetol: no mention of ALT elevations or hepatotoxicity).
Bogan RK, Thorpy MJ, Dauvilliers Y, Partinen M, Del Rio Villegas R, Foldvary-Schaefer N, et al. Efficacy and safety of calcium, magnesium, potassium, and sodium oxybates (lower-sodium oxybate [LXB]; JZP-258) in a placebo-controlled, double-blind, randomized withdrawal study in adults with narcolepsy with cataplexy. Sleep. 2021;44(3):zsaa206. (Among 201 adults with narcolepsy and cataplexy switched to are treated with lower-sodium oxybate or placebo, those switched to placebo had worsening of numbers of cataplexy events and sleepiness scores while those switched from high to low sodium oxybate were stable and adverse events were typical of oxybate; no mention of ALT elevations or hepatotoxicity).
Guiraud J, Addolorato G, Aubin HJ, Batel P, de Bejczy A, Caputo F, Goudriaan AE, et al., SMO032 study group. (2021). Treating alcohol dependence with an abuse and misuse deterrent formulation of sodium oxybate: Results of a randomised, double-blind, placebo-controlled study. Eur Neuropsychopharmacol. (Among 509 adults with alcohol dependence undergoing withdrawal and treated with oxybate [0.75, 1.25, 1.75 or 2.25 g] or placebo three times daily for 12 weeks, there were no differences in rates of abstinence between the 5 groups [~71% to 73%] and side effects more frequent with oxybate include dizziness, vertigo, nausea, fatigue and somnolence; no mention of ALT levels or hepatotoxicity).
Kushida CA, Shapiro CM, Roth T, Thorpy MJ, Corser BC, Ajayi AO, Rosenberg R, et al. Once-nightly sodium oxybate (FT218) demonstrated improvement of symptoms in a phase 3 randomized clinical trial in patients with narcolepsy. Sleep 2021 Aug 6: ePub ahead of print. (Among 212 patients with narcolepsy treated with once nightly oxybate [4.5, 6, 7.5 and 9 g] or placebo, maintenance of wakefulness, excessive sleepiness and cataplexy were improved by oxybate and common adverse events were nausea, vomiting, headache, dizziness, and enuresis, while there were “no clinically meaningful changes from baseline in clinical laboratory values”).

## OTHER REFERENCE LINKS

1 Recent References on Oxybate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Oxybate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Oxybate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Oxybate)